# Pemigatinib

## OVERVIEW

### Introduction

Pemigatinib is a fibroblast growth factor (FGF) receptor kinase inhibitor that is used to treat unresectable, locally advanced or metastatic intrahepatic cholangiocarcinoma, as well as myeloid or lymphoid neoplasms with FGFR rearrangements. Pemigatinib is associated with transient and usually mild-to-moderate elevations in serum aminotransferase levels during therapy, but has not been convincingly linked to cases of clinically apparent liver injury with jaundice.

### Background

Pemigatinib (pem” i ga’ ti nib) is an orally available, small molecule inhibitor of the fibroblast growth factor (FGF) receptors 1, 2 and 3. Pemigatinib is used as therapy of advanced or metastatic cancers that harbor amplications, translocations, fusing or other activating point mutations of FGF receptors. Cholangiocarcinomas often harbor mutations in the FGF receptor 2 that cause the receptor to be activated and promote uncontrolled growth and tumorigenesis. Inhibition of the mutant receptor causes regression of cell proliferation and promotes cell death, effects that can be shown in cell culture and in animal models using cancer cells with FGF receptor activating mutations. After trials of pemigatinib in patients with refractory, advanced cholangiocarcinoma demonstrated a moderate rate of durable clinical responses, it received accelerated approval for use in the United States in 2020. Current indications are limited to adults with previously treated, unresectable, locally advanced, or metastatic cholangiocarcinoma and myeloid or lymphoid neoplasms with FGF receptor gene fusions and other rearrangements. Pemigatinib is available in tablets of 4.5, 9.0 and 13.5 mg under the brand name Pemazyre. The recommended dose for cholangiocarcinoma is 13.5 mg once daily for the first 14 days of 21 day cycles. For other neoplasms, the recommended dose is 13.5 mg per day continuously until disease progression or unacceptable toxicity. Adverse events are common and often include hyperphosphatemia (an effect of inhibition of FGF signaling), as well as symptoms of fatigue, nausea, diarrhea, constipation, dysgeusia, anorexia, abdominal pain, musculoskeletal pain, dizziness, alopecia, dryness of the eyes, mouth, and skin, blurred vision, nail toxicity, and hand-foot syndrome. Severe adverse events include ocular toxicity, severe hyperphosphatemia and embryo-fetal toxicity.

### Hepatotoxicity

In preregistration clinical trials of pemigatinib, ALT elevations arose in 43% to 50% of patients and were above 5 times ULN in 4% to 12%. Elevations in serum bilirubin were also common, but usually in the context of cholangiocarcinoma with partial or complete biliary obstruction. There were no cases of clinically apparent liver injury with jaundice and no deaths from liver failure attributable to pemigatinib therapy. The elevations were typically self-limited and resolved rapidly with or without dose adjustments. Since its approval, there have been no reports clinically apparent liver injury attributed to pemigatinib. However, the total clinical experience with its use has been limited and the frequency of serum aminotransferase elevations during therapy suggest that clinically significant liver injury may occur.

Likelihood score: E* (unproven but possible rare cause of clinically apparent liver injury).

### Mechanism of Injury

The causes of serum enzyme elevations or liver injury from pemigatinib therapy are not known. Some of the adverse effects of pemigatinib are due to its effects on FGF signaling (hyperphosphatemia) and others may be due to off-target effects on other kinases. Pemigatinib is metabolized in the liver largely by CYP 3A4, and liver injury might be caused by production of a toxic or immunogenic intermediate. Because it is a substrate for CYP 3A4, pemigatinib is susceptible to drug-drug interactions with agents that inhibit or induce this specific hepatic drug-metabolizing microsomal activity.

### Outcome and Management

Pemigatinib is associated with a moderate rate of serum aminotransferase elevations during therapy that are generally transient and not associated with symptoms or jaundice. While regular monitoring of liver tests is not specifically recommended, elevations if confirmed should lead to follow up monitoring. Serum aminotransferase elevations above 5 times the upper limit of normal or any elevations accompanied by jaundice or symptoms should lead to dose reduction or temporary cessation until they resolve or another cause of the abnormalities is found. There is no evidence to suggest a cross reactivity in risk for adverse events, hypersensitivity or hepatic injury between pemigatinib and other kinase inhibitors including the FGF receptor inhibitors such as erdafitinib, futibatinib, or infigratinib.

Drug Class: Antineoplastic Agents, Protein Kinase Inhibitors

Other FGF Receptor Kinase Inhibitors: Erdafitinib, Futibatinib, Infigratinib

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Pemigatinib – Pemazyre®

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Pemigatinib)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Pemigatinib | 1513857-77-6 | C24-H27-F2-N5-O4

## ANNOTATED BIBLIOGRAPHY

References updated: 30 November 2022

Abbreviations: FGF, fibroblast growth factor.

Zimmerman HJ. Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Review of hepatotoxicity published in 1999 before the availability of small molecule FGF receptor inhibitors).
DeLeve LD. Erlotinib. Cancer chemotherapy. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 556. (Review of hepatotoxicity of cancer chemotherapeutic agents discusses several tyrosine kinase inhibitors including imatinib, gefitinib, erlotinib and crizotinib, but not pemigatinib).
Wellstein A, Giaccone G, Atkins MB, Sausville EA. Pathway-targeted therapies: monoclonal antibodies, protein kinase inhibitors, and various small molecules. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1203-36. (Textbook of pharmacology and therapeutics).
FDA. https://www.accessdata.fda.gov/drugsatfda_docs/nda/2020/213736Orig1s000MultidisciplineR.pdf (FDA website with product labels, letters and multidisciplinary review of the applications for pemigatinib mentions that adverse events were common, led to drug discontinuation in 9%, interruptions in 43% [some due to ALT elevations], dose reductions in 14%, and ALT elevations in 43-50% of treated subjects which were above 5 times ULN in 4-12%, but all were self-limited and there were no drug related serious hepatic adverse events or instances of clinically apparent liver injury with jaundice).
Shah RR, Morganroth J, Shah DR. (2013). Hepatotoxicity of tyrosine kinase inhibitors: clinical and regulatory perspectives. Drug Saf. (Review of the hepatotoxicity of 18 tyrosine kinase inhibitors approved for use in cancer in the US as of 2013, before the availability of pemigatinib).
Arai Y, Totoki Y, Hosoda F, Shirota T, Hama N, Nakamura H, Ojima H, et al. (2014). Fibroblast growth factor receptor tyrosine kinase fusions define a unique molecular subtype of cholangiocarcinoma. Hepatology. (Whole transcriptome sequencing from 8 cholangiocarcinomas identified two FGF receptor fusion genes and screening of different human cancer tissues found FGF receptor fusions in 9 of 102 cholangiocarcinomas [all intrahepatic] but only 1 of 149 colorectal, 1 of 96 hepatocellular, and none of 212 gastric cancers; expression of the fusion kinases in cell cultures led to anchorage independent growth and tumorigenesis when implanted in mice).
(2018). Pemigatinib (Pemazyre) for cholangiocarcinoma. Med Lett Drugs Ther. (Concise review of the mechanism of action, pharmacokinetics, clinically efficacy, safety and costs of pemigatinib shortly after it was approved for use in cholangiocarcinoma, adverse events being common but no mention of hepatotoxicity or serum ALT elevations).
Liu PCC, Koblish H, Wu L, Bowman K, Diamond S, DiMatteo D, Zhang Y, et al. (2020). INCB054828 (pemigatinib), a potent and selective inhibitor of fibroblast growth factor receptors 1, 2, and 3, displays activity against genetically defined tumor models. PLoS One. (Review of the FGF cell pathway, effects of inhibiting the FGF receptor and the implications of such inhibition for cancer chemotherapy).
Abou-Alfa GK, Sahai V, Hollebecque A, Vaccaro G, Melisi D, Al-Rajabi R, Paulson AS, et al. (2020). Pemigatinib for previously treated, locally advanced or metastatic cholangiocarcinoma: a multicentre, open-label, phase 2 study. Lancet Oncol. (Among 146 adults with locally advanced or metastatic cholangiocarcinoma treated with pemigatinib, objective responses arose in 36% of patients with FGF receptors aberrations but in none of those without, adverse events were common and included hyperphosphatemia [55%], nausea, fatigue and nail changes; ALT elevations arose in only 2% of treated patients).
Hoy SM. (2020). Pemigatinib: first approval. Drugs. (Review of the chemical structure, mechanism of action, clinical efficacy and costs of pemigatinib which is a specific inhibitor of FGF receptors 1, 2 and 3, but also has activity against other targets perhaps accounting for some of its adverse effects).
Krook MA, Reeser JW, Ernst G, Barker H, Wilberding M, Li G, Chen HZ, et al. (2021). Fibroblast growth factor receptors in cancer: genetic alterations, diagnostics, therapeutic targets and mechanisms of resistance. Br J Cancer. (Review of the association of FGF receptors and cancer chemotherapeutic agents, activating mutations being found in 5-10% of cancers overall, but in 10-20% of cholangiocarcinomas).
Yang X, Yang X, Zhao H. (2022). Pemigatinib-related calcification in the liver. Am J Gastroenterol. (54 year old man with refractory cholangiocarcinoma achieved a remission after 3 months of treatment with pemigatinib, but 8 months later was found to have calcifications in the liver around the tumor 8, probably the result of hyperphosphatemia).

## OTHER REFERENCE LINKS

1 Recent References on Pemigatinib: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Pemigatinib+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Pemigatinib: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Pemigatinib)